# Low Molecular Weight Heparins

## OVERVIEW

### Introduction

The low molecular weight heparins enoxaparin, dalteparin and tinzaparin are purified fragments of natural heparins that have anticoagulant activity and are used to treat patients at high risk of venous thrombosis. The low molecular weight heparins are associated with serum enzyme elevations during therapy that are usually asymptomatic and resolve rapidly upon stopping; the low molecular weight heparins have not been implicated in cases of acute, clinically apparent, idiosyncratic liver injury.

### Background

Low molecular weight heparins are prepared from natural heparins isolated from porcine intestine or bovine lung by controlled depolymerization of the large natural heparin molecule (which has varying molecular weights averaging ~15,000 daltons) into smaller fragments and subsequent fractionation to obtain homogenous heparin fragments with biological activity and molecular weight averaging 4,000-5,000 daltons (range, 2,000-9,000 daltons). The low molecular weight heparins have the advantage of more favorable pharmacokinetics and fewer side effects, which allow for once daily administration and outpatient use. The onset of anticoagulation may be slower with low molecular weight compared to standard heparin, but the degree of anticoagulation is easier to maintain and manage. The mechanism of action of low molecular weight heparins is similar to that of standard heparin and involves binding to antithrombin III and inhibition of activated coagulation factors including thrombin and Factor IX. Current indications include prevention of deep vein thromboses in high risk individuals (such as after surgery or during immobilization), prevention of ischemic complications in patients with unstable angina (in combination with aspirin), and active treatment of deep vein thrombosis with or without pulmonary embolism (in combination with warfarin). Common side effects of the low molecular weight heparins include dizziness, fatigue, headache, indigestion, nausea, bleeding, ecchymoses, rash and urticaria. The dose regimen of the low molecular weight heparins varies by product, concentration units (mg vs anti-Factor IX IU) and indication. The typical regimen of treatment is once daily for 7 to 14 days, but longer term treatment is sometimes used in high risk situations including during cancer chemotherapy where there is a high risk of venous thomboses.

Enoxaparin (ee nox' a par' in) was the first small molecular weight heparin (average 4,500 daltons) to be approved for use in the United States (1993) and is available in liquid solution in several forms (ampoules, syringes) generically and under the brand name Lovenox.

Dalteparin (dal' te par' in) (average 5,000 daltons) was approved in the United States in 1994 and is available in liquid solution in single or multidose vials under the brand name Fragmin.

Tinzaparin (tin" za par' in) (average 4,500-5,500 daltons) was approved for use in the United States in 2000 and has more restricted indications. Tinzaparin is available as solution for injection in multidose vials under the brand name Innohep.

### Hepatotoxicity

The low molecular weight heparins have been associated with serum aminotransferase elevations in 4% to 13% of patients, but values greater than 5 times the upper limit of normal (ULN) are not common and occur mostly among patients receiving the highest doses. These elevations generally arise within 3 to 7 days of starting therapy and are usually mild, do not cause symptoms, and resolve rapidly once therapy is stopped. The enzyme elevations may improve with dose adjustment and sometimes resolve despite continuation of treatment using the same dosage. Recurrence of liver injury with restarting therapy is not invariable and the clinical implications of these abnormalities are not clear. The relative rates of serum enzyme elevations among the different low molecular weight heparins has not been clearly defined, but the abnormalities can occur with all of the currently available products, although perhaps at a lower rate than with standard heparin. Neither standard nor the low molecular weight heparins have been convincingly implicated in cases of acute, clinically apparent idiosyncratic liver injury with jaundice.

Likelihood score: E (although a frequent cause of asymptomatic serum enzyme elevations, the low molecular weight heparins are unlikely causes of clinically apparent liver injury).

### Mechanism of Injury

The low molecular weight heparins, like standard heparin, are likely to have a direct toxic effect on hepatocytes accounting for the frequency of serum enzyme elevations during therapy, particularly with higher doses. The mechanism of this injury is not known but has been reproduced in animal models.

### Outcome and Management

The serum aminotransferase elevations that occur during low molecular weight heparin therapy are usually self-limited and do not require dose modification or discontinuation of therapy. No convincing instances of clinically apparent or severe acute liver injury have been linked to the low molecular weight heparins in the published literature.

References to the safety and hepatotoxicity of the low molecular weight heparins are provided together at the end of the overview section on heparins.

Drug Class: Antithrombotic Agents, Anticoagulants

Other Drugs in the Subclass: Heparins, Heparin

## CASE REPORT

### Case 1. Asymptomatic aminotransferase elevations during enoxaparin therapy.

[Modified from: Hahn KJ, Morales SJ, Lewis JH. Enoxaparin-indued liver injury: case report and review of the literature and FDA Adverse Event Reporting System (FAERS). Drug Saf 2015: 2:17. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/27747729)].

A 45 year old man with a dural venous thrombosis was anticoagulated starting with a heparin drip that was converted to a low molecular weight heparin, enoxaparin in a dose of 1 mg per kilogram subcutaneously twice daily. Before anticoagulation his liver tests were completely normal (Table). After 4 days of enoxaparin therapy serum aminotransferase levels were found to be elevated, although he had no symptoms of liver disease. He denied a history of liver disease, drug allergies, alcohol abuse and risk factors for viral hepatitis. His other medications were not provided. A physical examination was evidently unrevealing. Laboratory testing showed an ALT 569 U/L, AST 340 U/L, Alk P 89 U/L [R ratio=20], bilirubin 0.7 mg/dL [direct 0.1 mg/dL] and INR 1.1. Tests for hepatitis A, B and C and for EBV and CMV infection were negative as were routine autoantibodies. Abdominal ultrasound showed no evidence of biliary obstruction or other abnormalities. Enoxaparin was continued for several days, but ALT and AST levels continued to rise and the low molecular weight heparin was discontinued on day 7. Thereafter, serum enzymes elevations improved and they were near normal 2 weeks later. He was never jaundiced or symptomatic. He was later found to have adenocarcinoma of the colon which was considered a possible cause of a hypercoagulable state accounting for the dural venous thrombosis.

#### Key Points

Medication: | Enoxaparin (1 mg/kg twice daily)
Pattern: | Hepatocellular (R=20)
Severity: | 1+ (enzyme elevations without jaundice)
Latency: | 4 days
Recovery: | Almost complete by 2 weeks
Other medications: | Not mentioned

#### Laboratory Values

Days Since Starting | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | 33 | 78 | 0.3 | Admission
1 | | | | Enoxaparin started
5 | 579 | 89 | 0.7
6 | 644 | 104 | 0.5
7 | 770 | 103 | 0.4 | Enoxaparin stopped
13 | 273 | 119 | 0.4 | Fondaparinux started
22 | 70 | 97 | 0.5
Normal Values | <41 | <126 | <1.2

#### Comment

This patient was found to have elevations in serum aminotransferase levels, without symptoms, jaundice or other liver test abnormalities, 4 days after starting subcutaneous enoxaparin for treatment and prevention of venous thromboses. Serum ALT and AST values continued to rise for the next two days, enoxaparin was stopped and the injury rapidly resolved. Liver injury did not recur upon switching therapy to fondaparinux, an oral anticoagulant that acts by inhibition of factor Xa. Typical of the liver injury that occurs in patients receiving low molecular weight heparins was the rapid onset (within 3 to 5 days of starting), rapid recover (generally within 1 to 4 weeks) and the absence of symptoms and jaundice. Some patients have mild increases in serum bilirubin and alkaline phosphatase, but they usually remain within the normal range. Indeed, without prospective monitoring, the injury may go undetected and resolve, even without discontinuation or dose modification. The injury seems to be partially dose related and the injury is not accumulative. The cause of the liver injury with heparins is unknown, but it resembles similar bouts of "transaminitis" due to high doses of penicillin (such as oxacillin) and bile acid resins (such as cholestyramine).

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dalteparin – Fragmin®

Enoxaparin – Generic, Lovenox®

Tinzaparin – Innohep®

DRUG CLASS

Antithrombotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tinzaparin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Dalteparin | 9005-49-6 | Unspecified | No Structure
Enoxaparin | 679809-58-6 | Unspecified | No Structure
Tinzaparin | 9005-49-6 | Unspecified | No Structure

## OTHER REFERENCE LINKS

1. Recent References on Dalteparin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Dalteparin/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/5/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. : from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Dalteparin) Trials on Dalteparin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Dalteparin)

1. Recent References on Enoxaparin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Enoxaparin/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/5/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. : from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Enoxaparin) Trials on Enoxaparin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Enoxaparin)

1. Recent References on Tinzaparin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tinzaparin/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/5/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. : from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tinzaparin) Trials on Tinzaparin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tinzaparin)